# Acamprosate

## OVERVIEW

### Introduction

Acamprosate is a synthetic amino acid and a neurotransmitter analogue that is used as an alcohol deterrent in management of alcohol dependence and abuse. Acamprosate has not been linked to serum enzyme elevations during therapy and has not been linked to cases of clinically apparent liver injury.

### Background

Acamprosate (a kam' proe sate) is N-acetylhomotaurine, a synthetic amino acid analogue similar to gamma aminobutyric acid (GABA) and taurine that has been shown to decrease alcohol craving in animal models. Acamprosate appears to function as a neurotransmitter which acts as a GABA agonist and partial glutamate (N-methyl-D-aspartate [NMDA]) antagonist, but its precise mechanism of action in decreasing alcohol craving is unknown. When used in a comprehensive alcohol treatment program, acamprosate has been shown to decrease relapse to alcohol use, at least over the short term. Acamprosate was approved for use in the therapy of alcohol dependence and abuse in the United States in 2004. Current indications are for maintenance of alcohol abstinence in patients with alcohol dependence who are abstinent at the time of drug initiation. Acamprosate is available in delayed release tablets of 333 mg generically and under the brand name Campral. The typical maintenance dose is 666 mg three times daily and it is recommended to be used only as a part of a comprehensive alcohol treatment program. The most common side effects are fatigue, anorexia, diarrhea, flatulence, nausea, headache, dizziness, insomnia, paresthesia, itching and sweating. Rare but potentially serious adverse events include suicidal ideation and behavior and hypersensitivity reactions.

### Hepatotoxicity

Acamprosate therapy has not been associated with serum enzyme elevations over and above rates that occur with placebo therapy. Despite widescale use in alcohol treatment programs, there have yet to be published reports of clinically apparent acute liver injury attributed to acamprosate therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Acamprosate is a synthetic amino acid, is minimally metabolized in the liver, and is excreted in the urine largely unchanged perhaps accounting for its lack of hepatotoxicity.

Drug Class: Substance Abuse Treatment Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acamprosate – Generic, Campral®

DRUG CLASS

Substance Abuse Treatment Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Acamprosate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Acamprosate | 77337-76-9 | C5-H11-N-O4-S

## ANNOTATED BIBLIOGRAPHY

References updated: 07 September 2021

Zimmerman HJ. Drugs used in aversion therapy. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 724-6. (Expert review of hepatotoxicity published in 1999: discussion of hepatotoxicity of alcohol aversion pharmacotherapy is limited to disulfiram).
Mihic SJ, Koob GF, Mayfield J, Harris RA. Ethanol. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 421-31. (Textbook of pharmacology and therapeutics).
Paille FM, Guelfi JD, Perkins AC, Royer RJ, Steru L, Parot P. (1995). Double-blind, randomized multicentre trial of acamprosate in maintaining abstinence from alcohol. Alcohol Alcohol. (Controlled trial of 2 doses of acamprosate vs placebo in 538 patients with alcohol abuse; only side effect that was more frequent with drug compared to placebo was diarrhea [8-12% vs 3%]; no mention of ALT levels and no cases of jaundice or hepatitis).
Whitworth AB, Fischer F, Lesch OM, Nimmerrichter A, Oberbauer H, Platz T, Potgieter A, et al. (1996). Comparison of acamprosate and placebo in long-term treatment of alcohol dependence. Lancet. (Randomized controlled trial of 1 year course of acamprosate vs placebo in 448 recently abstinent alcoholic patients; only 40% of patients finished 1 year of therapy, abstinent rates were higher with acamprosate than placebo [18% vs 7%]; "Acamprosate had no effect on haematology or serum biochemistry").
Chick J, Howlett H, Morgan MY, Ritson B. (2000). United Kingdom Multicentre Acamprosate Study (UKMAS): a 6-month prospective study of acamprosate versus placebo in preventing relapse after withdrawal from alcohol. Alcohol Alcohol. (Randomized controlled trial of 6 month course of acamprosate vs placebo in 581 recently abstinent alcoholic patients, found decrease in alcohol craving with acamprosate but no differences in rates of relapse; "No changes which could be attributed to the drug occurred in ... biochemistry test results").
Bouza C, Angeles M, Muñoz A, Amate JM. (2004). Efficacy and safety of naltrexone and acamprosate in the treatment of alcohol dependence: a systematic review. Addiction. (Systematic review of 33 studies of acamprosate and naltrexone; compliance rates were low, but acamprosate was associated with increased abstinence rates and had a "good safety pattern"; no mention of hepatotoxicity).
Verheul R, Lehert P, Geerlings P, Koeter MW, van den Brink W. (2005). Predictors of acamprosate efficacy: results from a pooled analysis of seven European trials including 1485 alcohol-dependent patients. Psychopharmacology. (Combined analysis of 7 controlled trials of acamprosate in 1485 patients; no discussion of side effects).
Rosenthal RN, Gage A, Perhach JL, Goodman AM. (2008). Acamprosate; safety and tolerability in the treatment of alcohol dependence. J Addict Med. (Analysis of 13 controlled trials of acamprosate in 4234 patients [1962 on placebo]; no clinically meaningful differences in clinical chemistry results were reported).
Kranzler HR, Gage A. (2008). Acamprosate efficacy in alcohol-dependent patients: summary of results from three pivotal trials. Am J Addict. (Reanalysis of 3 pivotal trials conducted in Europe in support of the US approval of acamprosate including 998 patients treated for 13-52 weeks; on reanalysis, complete abstinence rates were higher with acamprosate in all 3 studies [risk ratios: 1.7-2.9]; no discussion of side effects or hepatotoxicity).
Kennedy WK, Leloux M, Kutscher EC, Price PL, Morstad AE, Carnahan RM. (2010). Acamprosate. Expert Opin Drug Metab Toxicol. (Review of biochemistry, pharmacology, metabolism, efficacy and safety of acamprosate; no evidence of hepatotoxicity; indeed, abstinence is usually associated with decreases in liver enzymes).
Rösner S, Hackl-Herrwerth A, Leucht S, Lehert P, Vecchi S, Soyka M. (2010). Acamprosate for alcohol dependence. Cochrane Database Syst Rev. (Systematic analysis of efficacy and safety of acamprosate for alcohol dependence, states that diarrhea is the only side effect occurring more frequently with acamprosate therapy; does not mention ALT elevations or hepatotoxicity).
Witkiewitz K, Saville K, Hamreus K. (2012). Acamprosate for treatment of alcohol dependence: mechanisms, efficacy, and clinical utility. Ther Clin Risk Manag. (Review of safety and efficacy of acamprosate; "pharmavigilance data from over 1.5 million patients has revealed no serious health risks").
Yahn SL, Watterson LR, Olive MF. (2013). Safety and efficacy of acamprosate for the treatment of alcohol dependence. Subst Abuse. (Review of safety and efficacy of acamprosate; no mention of hepatotoxicity or ALT elevations).
Jonas DE, Amick HR, Feltner C, Bobashev G, Thomas K, Wines R, Kim MM, et al. (2014). Pharmacotherapy for adults with alcohol use disorders in outpatient settings: a systematic review and meta-analysis. JAMA. (Systematic review of the safety and efficacy of pharmacotherapies of alcohol dependence and abuse concludes that acamprosate helps to decrease alcohol relapse; no mention of hepatototixicity or ALT elevations).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to acamprosate).
Goh ET, Morgan MY. (2017). Review article: pharmacotherapy for alcohol dependence – the why, the what and the wherefore. Aliment Pharmacol Ther. (Review of medical therapies for alcohol dependence mentions that acamprosate is not metabolized in the liver and is generally safe in persons with impaired hepatic function, and that despite 30 years of clinical use it has not been reported to have serious adverse effects).
Antonelli M, Ferrulli A, Sestito L, Vassallo GA, Tarli C, Mosoni C, Rando MM, et al. (2018). Alcohol addiction – the safety of available approved treatment options. Expert Opin Drug Saf. (Review of current pharmacologic treatments of alcohol addiction mentions that acamprosate has not been reported to be hepatotoxic and can be used safely in persons with mild liver disease).

## OTHER REFERENCE LINKS

1 Recent References on Acamprosate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Acamprosate/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Acamprosate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Acamprosate)